# Itraconazole

## OVERVIEW

### Introduction

Itraconazole is a orally administered, triazole antifungal agent used in the treatment of systemic and superficial fungal infections. Itraconazole therapy is associated with transient, mild-to-moderate serum elevations and can lead to clinically apparent acute drug induced liver injury.

### Background

Itraconazole (it" ra kon' a zole) is a synthetic triazole fungicidal agent which acts by inhibition of fungal C14-a- ergosterol demethylase, which leads to a decrease in ergosterol synthesis, a necessary component of fungal cell membranes. Itraconazole is used in the therapy of a broad spectrum of fungal infections including blastomycosis, aspergillosis, histoplasmosis, candidiasis and various superficial mycoses. Itraconazole was approved for use in the United States in 1992 and continues to be widely used as an antifungal agent. Current indications include blastomycosis, histoplasmosis, aspergillosis and onychomycosis. Itraconazole is available in capsules of 100 mg, tablets of 200 mg and oral suspensions of 10 mg/mL in generic forms and under the brand name Sporanox. The typical dose is 100 to 400 mg daily based upon the type and severity of the fungal infection. Common side effects include nausea, vomiting, diarrhea, rash and hypokalemia.

### Hepatotoxicity

Transient, mild-to-moderate elevations in serum aminotransferase levels occur in 1% to 5% of patients on itraconazole. These elevations are largely asymptomatic and self-limited, resolving even with continuation of therapy. Clinically apparent hepatotoxicity is rare but has been well described and can be severe and even fatal. The liver injury from itraconazole typically presents 1 to 6 months after starting therapy with symptoms of fatigue and jaundice. The pattern of serum enzyme elevations is typically cholestatic (Case 1), but cases of severe hepatitis with acute liver failure typically have a hepatocellular enzyme pattern (Case 2). Immunoallergic features (rash, fever, eosinophilia) are uncommon as is autoantibody formation. Recovery upon stopping therapy can be delayed for several weeks and generally takes 4 to 10 weeks, although in some cases recovery may be prolonged.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of clinically apparent hepatotoxicity from itraconazole is unknown; however, it may have some correlation to the ability of itraconazole to alter sterol synthesis and inhibit P450 enzyme activity. Because it is a potent inhibitor of CYP 3A4, it has the potential of causing significant drug-drug interactions leading to increased or decreased plasma levels of other drugs, which can increase toxicity and alter efficacy.

### Outcome and Management

The severity of the liver injury ranges from mild and transient enzyme elevations to severe acute hepatitis requiring transplantation or death. At least one instance of chronic cholestasis compatible with vanishing bile duct syndrome due to itraconazole has been reported. More typically, improvements begin 1 to 3 weeks after stopping itraconazole and complete recovery is achieved in 6 to 12 weeks. Rechallenge may lead to recurrence and should be avoided. There is little information on cross reactivity of hepatic injury between itraconazole and other antifungal azoles, such as ketoconazole, voriconazole, fluconazole and posaconazole. While a few reports suggest that there is little cross reactivity, other azoles should be started with caution in patients who have suffered clinically apparent hepatotoxicity attributed to itraconazole.

Drug Class: Antifungal Agents

## CASE REPORTS

### Case 1. Cholestatic hepatitis due to itraconazole.

[Modified from: Talwalkar JA, Soetikno RE, Carr-Locke DL, Berg CL. Severe cholestasis related to itraconazole for the treatment of onychomycosis. Am J Gastroenterol 1999; 94: 3632-3. [PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/10606333)]

A 74 year old woman developed atrial fibrillation during the first week of a course of itraconazole for onychomycosis and was found to have mild elevations in serum ALT (111 U/L) and alkaline phosphatase (283 U/L), but normal serum bilirubin (0.5 mg/dL). The atrial fibrillation was treated with verapamil and she returned to normal sinus rhythm; itraconazole was continued. Three weeks later, she developed jaundice and pruritus and itraconazole was stopped. She was jaundiced, but had no fever or rash. At this point, serum bilirubin had risen to approximately 8.5 mg/dL, ALT 350 U/L and Alk P 750 U/L yielding an R ratio of 1.7 (cholestatic). Tests for hepatitis A, B and C were negative as were autoantibodies. Imaging of the liver showed no evidence of biliary obstruction. Serum bilirubin continued to rise for 3 weeks after stopping itraconazole, peaking at 32 mg/dL and then slowly fell into the normal range (Table). Pruritus persisted for two months. Laboratory results became normal 3 months after onset.

#### Key Points

Medication: | Itraconazole (100 mg twice daily)
Pattern: | Cholestatic (R=1.7)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 1 week to ALT elevations, 4 weeks to symptoms and jaundice
Recovery: | 3 months
Other medications: | Verapamil

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk* P (U/L) | Bilirubin* (mg/dL) | Other
1 week | 0 | 111 | 283 | 0.5 | Symptoms
4 weeks | 0 | 140 | 350 | 0.5
Itraconazole therapy discontinued
6 weeks | 2 weeks | 350 | 750 | 8.5
6.5 weeks | 2.5 weeks | 500 | 1050 | 17.0
7 weeks | 3 weeks | 725 | 1519 | 32.0
8 weeks | 4 weeks | 500 | 1425 | 22.0
9 weeks | 5 weeks | 250 | 800 | 8.5
11 weeks | 7 weeks | 150 | 50 | 4.0
14 weeks | 10 weeks | 30 | 80 | 1.0
Normal Values | | <40 | <130 | <1.2

*Values estimated from Figure 1.

#### Comment

Very typical case of cholestatic hepatitis due to itraconazole with onset 4 weeks after starting the medication, and persistence of jaundice and pruritus for two months. Serum enzymes and bilirubin levels continued to rise for at least 3 weeks after stopping itraconazole, but then gradually fell into the normal range.

### Case 2. Acute liver failure due to itraconazole.

[Modified from: Srebrnik A, Levtov S, Ben-Ami R, Brenner S. Liver failure and transplantation after itraconazole treatment for toenail onychomycosis. J Eur Acad Dermatol Venereol 2005; 19: 205-7. [PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/15752292)]

A 25 year old woman presented with fatigue, jaundice and progressive stupor 3 weeks after completing four 1-week pulse courses of itraconazole (400 mg/day for 1 week every month) for onychomycosis. Blood tests showed marked elevations in serum bilirubin and serum aminotransferase levels and prolongation of the prothrombin time (Table). She was hospitalized and managed in an intensive care unit. Tests for hepatitis A, B and C were negative as were autoantibodies and tests for Wilson disease. A liver biopsy showed massive necrosis and she was transferred to a liver transplant unit where she underwent successful liver transplantation. In follow up her liver tests were normal.

#### Key Points

Medication: | Itraconazole (400 mg daily for one week once monthly for 4 months)
Pattern: | Hepatocellular (R=66)
Severity: | 5+ (acute liver failure requiring emergency liver transplantation)
Latency: | 3 weeks after completing 4 weekly courses
Recovery: | None
Other medications: | Thyroxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
15 weeks | 3 weeks | 2500 | 124 | 15.4 | INR=1.8
| 3.3 weeks | 2085 | 107 | 21.8 | INR=2.4
16 weeks | 4 weeks | 648 | Normal | 26.7 | Hepatic encephalopathy
Liver transplantation
After transplantation | | 59 | 234 | 1.2 | INR=1.2
Normal Values | | <40 | <130 | <1.2

#### Comment

The patient had been refused treatment with itraconazole twice before because of serum enzyme abnormalities but the nature of the abnormalities were not investigated. The appearance of liver injury after stopping itraconazole may merely reflect the intermittent dosing used. While intermittent or pulse itraconazole therapy is said to be safer than continuous therapy, there is little comparative data to support this; pulse therapy appears to be as effective and is less expensive and perhaps has improved adherence.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Itraconazole – Generic, Sporanox®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=itraconazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Itraconazole | 84625-61-6 | C35-H38-Cl2-N8-O4 | Image of Itraconazole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 17 May 2017

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999; mentions that itraconazole has been implicated in 5 cases of clinically apparent liver injury; 3 were cholestatic).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-81. (Review of hepatotoxicity of antifungal agents; reports that asymptomatic serum aminotransferase elevations occur in up to 7% of patients on itraconazole; reported cases of liver injury include at least 3 instances of vanishing bile duct syndrome).
Bennett JE. Antifungal agents. In, Brunton LL, Chabner KA, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1571-91. (Textbook of pharmacology and therapeutics; itraconazole is a synthetic triazole that has largely replaced ketoconazole, but it is potent inhibitor of CYP 3A4 and has been linked to serious hepatotoxicity).
Van Cauteren H, Lampo A, Vandenberghe J, Vanparys P, Coussement W, De Coster R, Marsboom R. Toxicological profile and safety evaluation of antifungal azole derivatives. Mycoses 1989; 32 Suppl 1: 60-6. (Review of toxicity of antifungal azoles from Janssen Research Foundation; itraconazole has less drug-drug interaction and effect on P450 activity in animal models than ketoconazole or fluconazole). 2561186
Tucker RM, Haq Y, Denning DW, Stevens DA. Adverse events associated with itraconazole in 189 patients on chronic therapy. J Antimicrob Chemother 1990; 26: 561-6. (Between 1984 and 1989, 189 patients were treated with itraconazole chronically with various fungal infections and monitored for side effects; most common were nausea [10%], serum aminotransferase elevations [5%, all <3 times normal and without jaundice], rash [2%] and diarrhea). 2174854
Lavrijsen AP, Balmus KJ, Nugteren-Huying WM, Roldaan AC, van't Wout JW, Stricker BH. Hepatic injury associated with itraconazole. Lancet 1992; 340: 251-2. (2 women and 1 man, ages 62, 75 and 57 years, developed fatigue, jaundice or fever after 5, 6 and 5 weeks of itraconazole therapy [bilirubin 2.1, 7.6 and normal, ALT 227, 106 and 272 U/L, Alk P 593, 716 and 280 U/L], all 3 resolving within 8-10 weeks of stopping). 1353183
Hann SK, Kim JB, Im S, Han KH, Park YK. Itraconazole-induced acute hepatitis. Br J Dermatol 1993; 129: 500-1. (51 year old woman developed jaundice after 116 days of itraconazole therapy [bilirubin 13.1 mg/dL, ALT 844 U/L, Alk P 214 U/L], with slow recovery on discontinuation). 8217769
Hay RJ. Risk/benefit ratio of modern antifungal therapy: focus on hepatic reactions. J Am Acad Dermatol 1993; 29: S50-4. (Review article on hepatotoxicity of antifungal agents, griseofulvin, ketoconazole, fluconazole, itraconazole and terbinafine; does not recommend routine ALT monitoring, but stresses need to discontinue agent for hepatic injury with symptoms). 8315062
Jacobs AE. [Liver damage during administration of itraconazole(Trisporal)]. Ned Tijdschr Geneeskd 1993; 137: 97-8. Dutch. 8380628
Lavrijsen AP, Balmus KJ, Nugteren-Huying WM, Roldaan AC, van 't Wout JW, Stricker BH. [Liver damage during administration of itraconazole (Trisporal)]. Ned Tijdschr Geneeskd 1993; 137: 38-41. Dutch. 8380490
Gallardo-Quesada S, Luelmo-Aguilar J, Guanyabens-Calvet C. Hepatotoxicity associated with itraconazole. Int J Derm 1995; 34: 589. (Patient of unstated sex and age developed fatigue and fever 5 days after starting itraconazole [bilirubin 2.3 mg/dL, ALT 318 U/L, Alk P 430 U/L], symptoms resolving rapidly and laboratory tests normal 6 weeks later). 7591446
Haneke E, Abeck D, Ring J. Safety and efficacy of intermittent therapy with itraconazole in finger- and toenail onychomycosis: a multicentre trial. Mycoses. 1998; 41: 521-7. (Among 683 patients with onychomycosis given intermittent 1 week itraconazole courses monthly for 3 months, only one developed ALT elevations [91 U/L], which apparently resolved spontaneously). 9919897
Nolting SK, Gupta A, Doncker PD, Jacko ML, Moskovitz BL. Continuous itraconazole treatment for onchomycosis and dermatomycosis: an overview of safety. Eur J Dermatol 1999; 9: 540-3. (Itraconazole has been used to treat more than 34 million patients; ALT elevations occur in 1.5% of patients on itraconazole and 0.7% on placebo, but every 4 week monitoring is recommended; estimated frequency of symptomatic hepatitis is 1:500,000 patients; intermittent regimens are as effective and may have fewer side effects, but few data to support this). 10523732
Talwalkar JA, Soetikno RE, Carr-Locke DL, Berg CL. Severe cholestasis related to itraconazole for the treatment of onychomycosis. Am J Gastroenterol 1999; 94: 3632-3. (74 year old woman developed abnormal serum enzymes after 1 week and jaundice and pruritus after 4 weeks of itraconazole therapy, bilirubin rising to 32 mg/dL [peak ALT 725 U/L; Alk P 1519 U/L] and pruritus persisting for two months and resolving slowly: Case 1). 10606333
Persat F, Schwartzbrod PE, Troncy J, Timour Q, Maul A, Piens A, Picot S. Abnormalities in liver enzymes during simultaneous therapy with itraconazole and amphotericin B in leukaemic patients. J Antimicrob Chemother 2000; 45: 928-9. (Experience in treating 20 patients with itraconazole [12 also on amphotericin] for 44-495 days; ALT elevations occurred in 11 of 12 who received combination therapy, levels 2-10 times normal, all resolving, some with stopping amphotericin alone). 10837458
Adriaenssens B, Roskams T, Steger P, Van Steenbergen W. Hepatotoxicity related to itraconazole: report of three cases. Acta Clin Belg 2001; 56: 364-9. (2 women and 1 man, ages 75, 77 and 59 years, developed jaundice 2-6 months after starting itraconazole [bilirubin 10, 18, and 5 mg/dL, ALT 177, 99 and 257 U/L, Alk P 1211, 1440 and 1177 U/L], slow resolution upon stopping, one with chronic cholestasis and ductopenia). 11881322
Wolf R, Wolf D, Kuperman S. Focal nodular hyperplasia of the liver after itraconazole treatment. J Clin Gastroenterol 2001; 33: 418-20. (38 year old woman found to have 2.1 cm hepatic mass diagnosed as focal nodular hyperplasia 2 months after stopping a 4 month course of intraconazole; not present on ultrasound done one year earlier). 11606862
Gupta A, Lambert J, Revuz J, Shear N. Update on the safety of itraconazole pulse therapy in onychomycosis and dermatomycosis. Eur J Dermatol 2001; 11: 6-10. (Intraconazole has been used for 15 years in more than 50 million patients; serum enzyme elevations occur in 1-5% of patients on continuous itraconazole therapy and 1.7-2% on pulse therapy; symptomatic hepatotoxicity is rare; ALT monitoring recommended for continuous but not pulse therapy). 11174129
Gupta A, Chwetzoff E, Del Rosso J, Baran R. Hepatic safety of itraconazole. J Cutan Med Surg 2002; 6: 210-3. (Analysis of 24 clinical trials in more than 3000 patients from Janssen, 15 using continuous and 11 pulse regimens; ALT elevations greater than twice normal [2 occasions] developed in 1% on pulse and 1.5% on continuous itraconazole and 1% on placebo). 11951124
Bradbury BD, Jick SS. Itraconazole and fluconazole and certain rare, serious adverse events. Pharmacotherapy 2002; 22: 697-700. (Among 16,001 users of itraconazole and 34,220 users of fluconazole in UK general practice database, only two cases of liver injury were identified, both were anicteric and self-limited; “Itraconazole and fluconazole do not commonly cause rare, serious adverse events affecting the liver...”). 12066960
Legras A, Bergemer-Fouquet AM, Jonville-Bera AP. Fatal hepatitis with leflunomide and itraconazole. Am J Med 2002; 113: 352-3. (68 year old woman with rheumatoid arthritis on leflunomide for 6 and itraconazole for 2 months developed acute liver failure [bilirubin not given, ALT 1111 rising to 5940 U/L, Alk P 62 U/L, prothrombin index 43%] leading to death; itraconazole may have altered leflunomide plasma levels and heightened its toxicity). 12361833
Jiménez-Sáenz M, Villar-Rodríguez JL, del Carmen Martínez-Sánchez M, Rebllo-Bernardez J, Carmona-Soria I, Herrerias-Esteban JM, Herrerias-Gutierrez JM. Itraconazole-induced acute hepatitis in an agricultural worker: susceptibility or drug interaction? J Clin Gastroenterol 2004; 38: 380-2. (39 year old man developed jaundice 8 weeks after a 3 day course of itraconazole and 4 weeks after exposure to herbicides [atrazine and simazine] [bilirubin 8.8 rising to 32.0 mg/dL, ALT 2426 U/L, Alk P 225 U/L], recovering with a course of prednisone). 15087702
Wingfield AB, Fernandez-Obregon AC, Wignall FS, Greer DL. Treatment of tinea imbricate: a randomized clinical trial using griseofulvin, terbinafine, itraconazole and fluconazole. Br J Dermatol 2004; 150: 119-26. (Randomized trial of four antifungals for 4 weeks for tinea imbricate in 86 patients in New Guinea; griseofulvin and terbinafine were effective; itraconazole and fluconazole were not; only one patient had ALT elevation [3 fold: terbinafine]). 14746625
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 6 were attributed to ketoconazole and 1 to itraconazole). 15390328
Fischer MA, Winkelmayer WC, Rubin RH, Avorn J. The hepatotoxicity of antifungal medications in bone marrow transplant recipients. Clin Infect Dis 2005; 41: 301-7. (Among 438 patients undergoing bone marrow transplantation, 123 developed ALT or AST above 3 times ULN; factors associated with significant increases were liposomal amphotericin [Odds Ratio=3.8] and fluconazole [2.6], but not standard amphotericin [2.0]). 16007524
Wingard J, Leather H. Hepatotoxicity associated with antifungal therapy after bone marrow transplantation. Clin Infect Dis 2005; 41: 308-10. (Editorial accompanying article by Fischer [2205] discussing difficulty of diagnosis of drug induced liver disease in patients after bone marrow transplant). 16007525
Song J, Deresinski S. Hepatotoxicity of antifungal agents. Curr Opin Investig Drugs 2005; 6: 170-7. (Extensive review of hepatotoxicity from antifungals; itraconazole causes ALT elevations in 2-3% of patients but clinically apparent liver injury is rare, although there have been at least 24 cases of liver failure due to itraconazole reported to the FDA). 15751740
Srebrnik A, Levtov S, Ben-Ami R, Brenner S. Liver failure and transplantation after itraconazole treatment for toenail onychomycosis. J Eur Acad Dermatol Venereol 2005; 19: 205-7. (Mentions that FDA has received reports of 24 cases of drug induced liver injury and 11 deaths due to itraconazole; Case of 25 year old who developed jaundice and stupor 3 weeks after stopping itraconazole [1 week every month for 4 months] with bilirubin 15.4 mg/L, ALT 2500 U/L and Alk P 124 U/L, and progressive hepatic failure, requiring liver transplantation: Case 2). 15752292
Cruciani M, Mengoli C, Malena M, Bosco O, Serpelloni G, Grossi P. Antifungal prophylaxis in liver transplant patients: a systematic review and meta-analysis. Liver Transpl 2006; 12: 850-8. (Meta analysis found 6 studies with total of 698 patients comparing fluconazole, itraconazole or amphotericin vs placebo for prevention of fungal infections after liver transplantation; side effects were more with prophylaxis, but liver toxicity was not discussed). 16628697
Girois SB, Chapuis F, Decullier E, Revol BG. Adverse effects of antifungal therapies in invasive fungal infections: review and meta-analysis. Eur J Clin Microbiol Infect Dis 2006; 25: 138-49. (Systematic review of adverse effects of antifungal therapy in 54 studies with 9228 patients; hepatotoxicity reported in 14.1-18.6% on amphotericin, 1.9% on fluconazole and 31.6% on itraconazole; but great variation in definitions and intensity of monitoring). 16622909
Wang A, Zhang Y, He L, Shen Z, Liao W, Han M, Ruoyu L, et al. Clinical study on the efficacy and safety of intravenous itraconazole infusion for the treatment of invasive fungal infection in China. Jpn J Infect Dis 2006; 59: 370-6. (Among 156 patients with severe fungal infections treated with itraconazole [intravenously for 2 weeks and orally for 4 weeks], liver enzymes were elevated in 10.9% and bilirubin in 8.3%). 17186955
Zhu LP, Yang FF, Weng XH, et al. [Hepatic safety of itraconazole intravenous solution in treatment of invasive fungal infection]. Zhonghua Yi Xue Za Zhi 2006; 86: 2028-32. 17064545
Tuccori M, Bresci F, Guidi B, Blandizzi C, Del Tacca M, Di Paolo M. Fatal hepatitis after long-term pulse itraconazole treatment for onychomycosis. Ann Pharmacother 2008; 42: 1112-7. (61 year old woman developed jaundice 1 week after 6 pulse courses of itraconazole [bilirubin 21 mg/dL, ALT 3330 U/L, GGT 230 U/L] and progressed to acute liver failure, undergoing transplantation 17 days after presentation; graft showed massive necrosis; died of complications two months posttransplant). 18523232
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease collected from 2004 to 2008 in the US, two cases were attributed to fluconazole, one to ketoconazole, one to itraconazole, none to voriconazole). 18955056
Cadena J, Levine DJ, Angel LF, Maxwell PR, Brady R, Sanchez JF, Michalek JE, et al. Antifungal prophylaxis with voriconazole or itraconazole in lung transplant recipients: hepatotoxicity and effectiveness. Am J Transpl 2009; 9: 2085-91. (Retrospective analysis of safety of prophylaxis with voriconazole and inhaled amphotericin B [35 patients] vs itraconazole [32] in lung transplant recipients; no itraconazole treated patient developed liver injury compared to 12 [34%] in the vorconazole group). 19645709
Björnsson E, Davidsdottir L. The long-term follow-up after idiosyncratic drug-induced liver injury with jaundice. J Hepatol 2009; 50: 511-7. (In long term follow up of 685 patients with drug induced liver injury in Sweden, 8 were found to have developed cirrhosis, 5 of whom died including a 34 year old man with fluconazole hepatotoxicity who died 4 years later of complications of cirrhosis, possibly alcoholic). 19155082
Antifungal drugs. Treat Guidel Med Lett 2009; 7: 95-102. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; itraconazole has a broader spectrum of activity than fluconazole; Stevens-Johnson syndrome and serious hepatic toxicity can occur).19940816
Wang JL, Chang CH, Young-Xu Y, Chan KA. Systematic review and meta-analysis of the tolerability and hepatotoxicity of antifungals in empirical and definitive therapy for invasive fungal infection. Antimicrob Agents Chemother 2010; 54: 2409-19. (Systematic review of 39 controlled trials in more than 8000 patients, found liver enzyme elevations in 18.9% of patients on itraconazole, but only 1.5% stopped therapy for this reason; rate for voriconazole was 19.7%, fluconazole 10%). 20308378
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 6 were attributed to antifungal agents, including 1 to itraconazole). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, voriconazole ranked 21st with 52 cases [odds ratio 10.7] and fluconazole 30th with 42 cases [odds ratio 8.6]; intraconazole was not listed in the top 41 causes). 21039766
Yoshikado T, Takada T, Yamamoto T, Yamaji H, Ito K, Santa T, Yokota H, et al. Itraconazole-induced cholestasis: involvement of the inhibition of bile canalicular phospholipid translocator MDR3/ABCB4. Mol Pharmacol 2011; 79: 241-50. (2 women and 1 man, ages 36 to 67 years, developed liver test abnormalities 2 to 62 days after starting itraconazole [bilirubin 0.8, 1.4 and 4.3 mg/dL, ALT 81, 874 and 269 U/L, Alk P 312, 539 and 178 U/L], resolving upon stopping and two with recurrence on restarting; two had high drug levels and in vitro results suggested inhibition of MDR3 function by itraconazole). 21056966
Lou HY, Fang CL, Fang SU, Tiong C, Cheng YC, Chang CC. Hepatic failure related to itraconazole use successfully treated by corticosteroids. Hepat Mon 2011; 11: 843-6. (46 year old woman developed jaundice 5 weeks after starting itraconazole for onychomycosis [bilirubin 4.4 rising to 12.8 mg/dL, ALT 3789 U/L, Alk P not given, INR 1.4 rising to 2.8], later developing erythema multiforme and clinical worsening, but eventually improving after initiation of corticosteroid therapy). 22224084
Antifungal drugs. Treat Guidel Med Lett 2012;10: 61-8. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; the most common side effects of itraconazole include nausea, diarrhea, vomiting and rash. "Stevens-Johnson syndrome and serious hepatic toxicity can occur"). 22825657
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to itraconazole or other antifungal agents). 23419359
Kao WY, Su CW, Huang YS, Chou YC, Chen YC, Chung WH, Hou MC, et al. Risk of oral anti-fungal agent-induced liver injury in Taiwanese. Br J Clin Pharmacol 2014; 77: 180-9. (Analysis of Taiwan National Health Insurance database from 2002-2008 identified 52 patients with drug induced liver injury among 90,847 users of oral antifungal agents, 3 of which [6%] were attributed to itraconazole [3.6 per 10,000 persons exposed], the rate increasing with increasing duration of therapy; none of 6 fatal cases were due to itraconazole). 23750489
Raschi E, Poluzzi E, Koci A, Caraceni P, Ponti FD. Assessing liver injury associated with antimycotics: Concise literature review and clues from data mining of the FAERS database. World J Hepatol 2014; 6: 601-12. (Analysis of the FDA database on adverse reactions [2004 to 2011] identified 68,115 reports of liver injury including 1964 due to antifungal agents, the most common being terbinafine [422], fluconazole [412], voriconazole [361], amphotericin B [265], itraconazole [182], ketaconazole [94] and posaconazole [70]; among 112 cases with acute liver failure causes included fluconazole [31], terbinafine [27], voriconazole [19], amphotericin [14], ketoconazole [6], posaconazole [5], and itraconazole [4]). 25232453
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 cases [1.6%] were attributed to antifungal agents including 6 triazoles [3 with jaundice and 2 hospitalized, no deaths], 4 due to fluconazole, 1 ketoconazole and 1 voriconazole but none were attributed to itraconazole). 25754159
Pettit NN, Pisano J, Weber S, Ridgway J. Hepatic failure in a patient receiving itraconazole for pulmonary histoplasmosis - case report and literature review. Am J Ther 2016; 23: e1215-21. (65 year old woman developed acute liver failure with mental confusion 6 months after starting itraconazole for pulmonary histoplasmosis [bilirubin 1.9 rising to 3.5 mg/dL, ALT 683 to 3695 U/L, Alk P 69 U/L, CPK 7685 U/L, ammonia 118 μg /dL, INR 2.0], resolving rapidly upon stopping). 26291595
Lo Re V 3rd, Carbonari DM, Lewis JD, Forde KA, Goldberg DS, Reddy KR, Haynes K, et al. Oral azole antifungal medications and risk of acute liver injury, overall and by chronic liver disease status. Am J Med 2016; 129: 283-91. (Among 1653 persons treated with oral itraconazole analyzed from a Kaiser Permanente clinical database, the incidence of ALT or AST elevations above 200 U/L was 2.5% and severe acute liver injury 0%; rates that were similar to those for ketoconazole and fluconazole, but less than for posaconazole and vorconazole). 26597673
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-65. (Review of the hepatotoxicity of antifungal agents states that all antifungal agents may cause hepatic toxicity and discusses fluconazole, itraconazole, voriconazole, posaconazole and isavuconazole, but not ketoconazole). 27927037

## OTHER REFERENCE LINKS

1. Recent References on Itraconazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(itraconazole)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Itraconazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=itraconazole)